# Black Cohosh

## OVERVIEW

### Introduction

Black cohosh is a popular herbal medication derived from a plant of the buttercup family indigenous to North America (Actaea racemosa, syn Cimicifuga racemosa), which is claimed to have estrogen-like effects and is used primarily for relief of symptoms of menopause. In recent years, products labeled as black cohosh has been implicated in many instances of clinically apparent, acute liver injury, some cases of which have been severe and led to emergency liver transplantation or death.

### Background

Black cohosh (Cimicifuga racemosa; Actaea racemosa) is a perennial plant indigenous to the eastern United States and Canada. It has been long employed as a traditional Native American medicine to treat malaise, gynecological disorders, kidney disorders, malaria, rheumatism, and sore throat. The plant is referred to by many names, including black root, black snakeroot, bugbane, cimicifuga, cohosh bugbane, macrotnys, and rattlesnake root. Black cohosh supplements are made from its roots and rhizomes. Black cohosh is commonly used for the relief of symptoms associated with menopause and has been shown to be effective in ameliorating these symptoms in controlled trials. The constituents of black cohosh include triterpenes glycosides and polyphenols. Black cohosh was initially believed to have estrogen-like activity and modulate tissue specific subtypes of the estrogen receptor; more recent investigations suggest that it may have serotonergic activity. Black cohosh is available in multiple preparations either as an herbal product on its own or as a component of an herbal supplement. Phytochemical analyses have shown that some black cohosh products are mislabeled and contain Chinese Actaea species instead (such as C. dahurica, C. foetida and C. heracleifolia). Side effects of black cohosh may include hypotension, bradycardia, central nervous system effects, nausea, and vomiting.

### Hepatotoxicity

In prospective clinical trials involving more than 1200 patients, black cohosh was not associated with serum enzyme elevations during treatment and no cases of clinically apparent liver injury were reported. However, products labeled as black cohosh have been linked to more than fifty instances of clinically apparent liver injury that have ranged in severity from symptomatic elevations in serum enzymes without jaundice, to acute self-limited hepatitis, prolonged hepatitis with cholestasis, autoimmune hepatitis, and acute liver failure requiring liver transplantation or with a fatal outcome. The latency to onset of liver injury ranged from 1 to 48 weeks, but was usually within 2 to 12 weeks. The clinical presentation was typically with jaundice and a markedly hepatocellular pattern of injury with liver biopsy histology resembling acute viral hepatitis. Some instances of an autoimmune hepatitis-like clinical syndrome have been described with high levels of autoantibodies, chronic hepatitis on liver biopsy and a clinical response to prednisone. In some cases, black cohosh appeared to have precipitated an autoimmune hepatitis that was self-sustained and relapsed when immunosuppression was withdrawn, while in other instances the hepatitis with autoimmune features resolved spontaneously after discontinuation of black cohosh or after a short course of prednisone. In several instances, the implicated product has been retrieved and found to contain Chinese Actaea species rather than black cohosh, and the role of Actaea racemosa in causing liver injury remains controversial.

Likelihood score: A (products sold as black cohosh are well established causes of clinically apparent liver injury, but the specific ingredient or component that accounts for the injury is unclear).

### Mechanism of Injury

Black cohosh does not appear to be inherently hepatotoxic, and the clinical features of cases suggest that the liver injury is an idiosyncratic reaction which may be immunologically mediated. The specific component of black cohosh responsible for the hepatic injury is not known. As with many HDS products, unknown adulterants or herbals mislabeled as black cohosh may be the actual cause of hepatic injury.

### Outcome and Management

The severity of liver injury ranges from moderate elevations in liver enzymes to acute hepatic failure and death. However, mild disease with spontaneous resolution with stopping the herbal is more common. Cases with autoimmune features or prolonged symptomatic cholestasis may benefit from a course of immunosuppression with prednisone, with or without azathioprine. However, the dose of prednisone should be kept to a minimum and attempts should be made to withdraw immunosuppression once the hepatitis has resolved. There is no evidence for cross sensitivity to the liver injury between black cohosh and more conventional estrogen preparations nor with other herbals.

Drug Class: Herbal and Dietary Supplements

## CASE REPORTS

### Case 1. Acute liver failure after taking an herbal preparation with black cohosh.(1)

A 52 year old woman developed fatigue and lethargy, followed by jaundice approximately 3 months after starting a liquid herbal preparation that contained black cohosh. She stopped the botanical when she became ill, but subsequently developed jaundice. The preparation was made and provided by a pharmacist and contained fluid extracts of several botanicals, including ground ivy (Nepeta hederacea), golden seal (Hydrastis canadensis), ginkgo (Ginkgo biloba), oats seed (Avena sativa), and black cohosh (Cimicifuga racemosa). She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis and was not taking other medications. On examination, she was deeply jaundiced, but had no signs of hepatic encephalopathy. Serum bilirubin was 21.5 mg/dL, ALT 1380 U/L, alkaline phosphatase 230 U/L and INR 3.0. Other causes of acute liver failure were said to be excluded. During the initial week, she developed evidence of hepatic failure with progressive hepatic encephalopathy and worsening coagulation, leading to liver transplantation approximately 4 weeks after admission. The explanted liver showed massive necrosis.

#### Key Points

Medication: | Herbal mixture with black cohosh
Pattern: | Hepatocellular (R=11.3)
Severity: | 5+ (liver transplantation for acute liver failure)
Latency: | 3 months
Recovery: | None
Other medications: | Other herbals in the liquid mixture included ground ivy, goldenseal, ginkgo and oats seed

#### Comment

This patient developed an acute liver failure of unknown cause approximately 3 months after starting an herbal preparation that was claimed to contain black cohosh. The other components have not been implicated in cases of acute liver failure, but may have contributed due to herb-herb interactions. This case was the initial report of hepatotoxicity attributed to black cohosh. The possibility that the liver injury was unrelated to black cohosh and due to a adulterant or mislabeled herbal or was due to a coincidental, idiopathic or unusual viral cause of acute liver failure cannot be completely excluded. However, the clinical presentation with a strongly hepatocellular pattern of injury and a gradual progression to hepatic failure over several weeks, even after stopping the herbal, has been described in other cases of severe acute liver injury attributed to black cohosh.

### Case 2. Acute liver failure arising during chronic therapy with black cohosh.(2)

A 54 year old woman developed fatigue and weight loss 6 months after starting black cohosh (1000 mg daily) for menopausal symptoms. She had a history of hypothyroidism and was receiving levothyroxine (100 μg daily). The fatigue persisted, and she noted onset of forgetfulness and loss of 10 pounds before seeking medical help. She had no history of liver disease, drank alcohol regularly but not to excess, and had no risk factors for viral hepatitis. On examination, she had tenderness over the liver but was not obviously jaundiced. Serum aminotransferase levels were markedly elevated (ALT 1003 U/L, AST 1014 U/L) with modest increases in alkaline phosphatase (266 U/L) and total bilirubin (2.4 mg/dL). Tests for hepatitis A, B and C were negative as were tests for herpes simplex, cytomegalovirus and Epstein-Barr virus infection. Autoantibodies were negative. Ultrasound and computerized tomography of the abdomen showed no evidence of biliary obstruction or abnormalities of the liver. The prothrombin time was elevated (INR 1.4). A liver biopsy showed severe bridging hepatocellular necrosis and with panlobular inflammation and interface hepatitis, but without fibrosis, compatible with a severe acute hepatitis. Prednisone was started, but her condition worsened. After two weeks, serum aminotransferase levels were still high and total bilirubin rose to 20.6 mg/dL. She developed hepatic encephalopathy and worsening coagulation (INR 2.6). Repeat ultrasonography showed reduced liver size. She underwent deceased donor liver transplantation 39 days after admission, but expired during the operation as a result of excessive hemorrhage. Autopsy showed a shrunken liver with extensive necrosis, minimal inflammation and regenerative nodules.

#### Key Points

Medication: | Black cohosh
Pattern: | Hepatocellular (R=10.9)
Severity: | 5+ (acute hepatic failure, liver transplantation and death)
Latency: | 6 months to initial symptoms, 8 months to jaundice
Recovery: | None
Other medications: | Levothyroxine 100 μg daily

#### Comment

Acute hepatitis with progressive hepatic failure arose 6 to 8 months after starting black cohosh for menopausal symptomatology. No other obvious cause was present and the patient was taking no other medication that might be considered hepatotoxic. While autoimmune hepatitis was considered and she was treated with prednisone, there were no autoantibodies or other features of this diagnosis and there appeared to be little response to immunosuppression. The clinical presentation and course was similar to other cases of liver injury attributed to black cohosh. The longer latency to onset was atypical, but similar variability in latency to onset of severe hepatotoxicity occurs with other agents that cause idiosyncratic acute liver injury, such as isoniazid and troglitazone.

### Case 3. Chronic hepatitis associated with black cohosh use.(3)

A 58 year old woman developed fatigue and weakness while taking black cohosh (80 mg of root extract daily) in addition to medications for hypertension (irbesartan 150 mg daily), hypothyroidism (levothyroxine 100 μg daily), hypercholesterolemia (simvastatin 20 mg daily), and diabetes (insulin). She had no history of liver disease, alcohol abuse, or risk factors for viral hepatitis. Physical examination was unremarkable. Laboratory testing, however, showed elevations in serum ALT (318 U/L), AST (214 U/L) and GGT (95 U/L) with normal bilirubin, albumin, total protein, INR, platelet and white blood cell counts. Tests for hepatitis A, B and C as well as Epstein Barr virus and cytomegalovirus infection were negative. Smooth muscle antibody was weakly positive (titer 1:40). A liver biopsy showed interface hepatitis and lobular inflammation with portal fibrosis suggestive of chronic hepatitis. Simvastatin was stopped, but she did not improve (Table). Accordingly, three months later black cohosh was discontinued. Within two weeks serum aminotransferase levels decreased and two months later her symptoms had resolved and liver tests were normal.

#### Key Points

Medication: | Black cohosh (80 mg daily)
Pattern: | Undefined, probably hepatocellular
Severity: | 1+ (enzyme elevations and symptoms without jaundice)
Latency: | Unclear
Recovery: | 2 months after stopping
Other medications: | Simvastatin, irbesartan, levothyroxine, insulin

#### Laboratory Values

Time After Presentation | ALT (U/L) | AST (U/L) | Bilirubin (mg/dL) | Other
0 | 183 | 214 | Normal | Asthenia
Simvastatin discontinued
3 months | 527 | 663
Black cohosh discontinued
3.3 months | 85 | 96
5 months | 45 | 43 | | Symptoms resolved
Normal Values | <34 | <44 | <1.2

#### Comment

The case report lacked information on duration of black cohosh use and several important clinical details (alkaline phosphatase levels, ANA results), but the timing of improvement in relationship to stopping black cohosh was very supportive of the link between the herbal and the chronic hepatic injury. Drugs that cause idiosyncratic acute hepatitis arising within 6 months of starting therapy may, if continued long term, also cause chronic hepatitis, sometimes with autoimmune features (examples being methyldopa, nitrofurantoin, isoniazid). In these instances, the time to onset of injury can be many months or years after starting the medication, particularly if it is given intermittently.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Black Cohosh – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/blackcohosh/ataglance.htm)

Fact Sheet at Office of Dietary Supplements, NIH (https://ods.od.nih.gov/factsheets/BlackCohosh-HealthProfessional/)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Black Cohosh | 84776-26-1 | Herbal mixture | Not applicable

## CITED REFERENCES

1 Lontos S, Jones RM, Angus PW, Gow PJ. Acute liver failure associated with the use of herbal preparations containing black cohosh. Med J Aust 2003; 179: 390-1.14503910
2 Lynch CR, Folkers ME, Hutson WR. Fulminant hepatic failure associated with the use of black cohosh: a case report. Liver Transpl 2006; 12: 989-92.16721764
3 Pierard S, Coche JC, Lanthier P, Dekoninck X, Lanthier N, Rahier J, Geubel AP. Severe hepatitis associated with the use of black cohosh: a report of two cases and an advice for caution. Eur J Gastroenterol Hepatol 2009; 21: 941-5. (Modified from case 2.)

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2025

Abbreviations used: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; black cohosh is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; black cohosh is mentioned as having been linked to cases of acute hepatitis, acute liver failure and autoimmune hepatitis, the mechanism of injury being unknown and the actual relationship to black cohosh being controversial).
Black cohosh. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 95-100. (Compilation of short monographs on herbal medications and dietary supplements).
Lieberman S. A review of the effectiveness of Cimicifuga racemosa (black cohosh) for the symptoms of menopause. J Womens Health 1998; 7: 525-9. (History of the development of black cohosh and series of open label and controlled trials showing its efficacy in decreasing symptoms of menopause). 9650153
American College of Obstetricians and Gynecologists Committee on Practice Bulletins–Gynecology. Clinical management guidelines for obstetrician-gynecologists: use of botanicals for management of menopausal symptoms. Obstet Gynecol 2001; 97: 1-11. (Review of evidence of benefit of various botanicals for menopausal symptoms: “Black cohosh may be helpful in the short-term treatment of women with vasomotor symptoms”). 11501568
Whiting PW, Clouston A, Kerlin P. Black cohosh and other herbal remedies associated with acute hepatitis. Med J Aust 2002; 177: 440-3. (6 cases of severe hepatitis in patients taking herbal medications, including 1 on black cohosh alone and 5 taking multiple herbals including skullcap [n=3], valerian [n=2], chaparral [n=1] and greater celandine [n=1] for 1-14 weeks, presenting with jaundice [bilirubin 9.9-62.7 mg/dL, ALT 1293-3764 U/L, Alk P 80-219 U/L], the 1 on black cohosh alone requiring emergency liver transplantation, the other 5 resolving in 7-25 weeks, 3 treated with prednisone for prolonged cholestasis). 12381254
Vitetta L, Thomsen M, Sali A. Black cohosh and other herbal remedies associated with acute hepatitis. Med J Aust 2003; 178: 411-2. (Letter in response to Whiting [2002] suggesting that hepatitis may have been due to a contaminant and without verification, the link to black cohosh cannot be made). 12697018
Thomsen M, Schmidt M. Hepatotoxicity from Cimicifuga racemosa? Recent Australian case report not sufficiently substantiated. J Altern Complement Med 2003; 9(3): 337-40. (Authors argue that case series of Whiting [2002] lacked essential information such as analytic verification of components and was weakened by insufficient exclusion of other causes, implausible mechanism of injury, overrating of dangers of herbals and lack of previous reports of hepatotoxicity in multiple prospective studies). 12816621
Lontos S, Jones RM, Angus PW, Gow PJ. Acute liver failure associated with the use of herbal preparations containing black cohosh. Med J Aust 2003; 179: 390-1. (52 year old woman developed jaundice 3 months after starting an herbal mixture including black cohosh [bilirubin 21.5 mg/dL, ALT 1380 U/L, Alk P 230 U/L, INR 3.0], with progressive hepatic failure and liver transplantation 1 month later: Case 1). 14503910
Pittler MH, Ernest E. Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther 2003; 18: 451-71. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma Huang [3], pennyroyal [1], skullcap [2], Chinese herbs [9], valerian [1]). 12950418
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg 2003; 138: 852-8. (Among 20 patients undergoing liver transplantation for acute liver failure during 2001-2, 10 were potentially caused by herbals; none were attributed to black cohosh). 12912743
Thomsen M, Vitetta L, Sali A, Schmidt M. Acute liver failure associated with the use of herbal preparations containing black cohosh. Med J Aust 2004; 180: 598-9. (Authors challenge the relationship between black cohosh and liver injury [Lontos 2003] on the basis that the herbal mixture also contained group ivy which has pulegone and that black cohosh has “a very good safety record”). 15175000
Thomsen M, Vitetta L, Sali A, Schmidt M. Acute liver failure associated with the use of herbal preparations containing black cohosh. Med J Aust. 2004;180:598-9. Author reply 599-600. (Reply to letter [Thomsen 2004] by the Office of Complementary Medicines indicating that the herbal product was analyzed and pulegone levels were below the level of detection). 15175000
Cohen SM, O’Connor AM, Hart J, Merel NH, Te HS. Autoimmune hepatitis associated with the use of black cohosh: a case study. Menopause 2004; 11: 575-7. (57 year old woman developed fatigue 3 weeks after starting black cohosh for hot flashes [bilirubin normal, ALT 1220 U/L, Alk P minor elevations], with ANA 1:640 and liver biopsy suggesting autoimmune hepatitis, resolving with prednisone therapy and relapsing with stopping [bilirubin 9.2 mg/dL, ALT 1694 U/L]). 15356412
National Center for Complementary and Integrative Health, NIH. Workshop on safety of black cohosh in clinical studies. November 22, 2004. Available at: https://files.nccih.nih.gov/s3fs-public/news/blackcohosh_mtngsumm.pdf (Workshop on black cohosh and its association with liver injury including two case reports from Australia: 47 year old woman developed acute liver failure 3 weeks after starting black cohosh for menopausal symptoms [bilirubin 32 mg/dL, ALT 1276 U/L, Alk P 153 U/L, INR 5.0], leading to emergency liver transplant and explant showing massive necrosis [Whiting 2002]; 52 year old woman developed acute liver failure presenting 1 month after taking a 3 month course of black cohosh [bilirubin 20 mg/dL, ALT 1380 U/L, Alk P 230 U/L, INR 3.0], undergoing liver transplant and explant showing massive necrosis).
Australian Therapeutic Goods Administration Statement. Required Advisory Statements for Medicine Labels. 2007. Available at: https://www.tga.gov.au/sites/default/files/consult-labelling-rasml-071107.pdf (Labeling requirement for black cohosh from the Therapeutic Goods Administration of Australia: “Warning: Black cohosh may harm the liver in some individuals. Use under the supervision of a healthcare professional”).
Huntley A. The safety of black cohosh(Actaea racemosa, Cimicifuga racemosa). Expert Opin Drug Saf 2004; 3: 615-23. (Review of experimental animal and human studies of black cohosh focusing upon mechanism of action, clinical efficacy and adverse events; in human trials few adverse events were reported and no liver side effects were encountered; in spontaneous reporting systems worldwide there have been 8 reports of liver and biliary adverse events). 15500420
Levitsky J, Alli TA, Wisecarver J, Sorrell MF. Fulminant liver failure associated with the use of black cohosh. Dig Dis Sci 2005; 50: 538-9. (50 year old woman developed jaundice 5 months after starting black cohosh [500 mg daily] for menopausal symptoms [bilirubin 7.6 g/dL, ALT 1474 U/L, Alk P 232 U/L, INR 2.5], with subsequent worsening despite prednisone therapy leading to liver transplantation 5 weeks after first presentation). 15810638
Low Dog T. Menopause: a review of botanical dietary supplements. Am J Med. 2005; 118 Suppl 12B: 98-108. (Systematic review of 19 controlled trials found evidence that black cohosh is beneficial for relief of menopause related symptoms, but recommendations are tempered by methodologic problems with the published trials, questions about its mechanism of action, and 4 recent reports of severe liver injury suspected to be due to black cohosh). 16414334
Lynch CR, Folkers ME, Hutson WR. Fulminant hepatic failure associated with the use of black cohosh: a case report. Liver Transpl 2006; 12: 989-92. (54 year old woman developed fatigue 6 months after starting black cohosh [1 g daily] and jaundice in next 2 months [bilirubin 2.4 mg/dL, ALT 1003 U/L, Alk P 266 U/L, INR 1.4], with subsequent worsening leading to liver transplantation; explant showed shrunken liver with marked centrilobular necrosis and regenerative nodules: Case 2). 16721764
Dugoua JJ, Seely D, Perri D, Koren G, Mills E. Safety and efficacy of black cohosh (Cimicifuga racemosa) during pregnancy and lactation. Can J Clin Pharmacol 2006; 13: e257-e261. (Systematic review of literature on efficacy and safety of black cohosh during pregnancy concluded that it should be used with caution; no mention of hepatotoxicity). 17085773
Nisbet BC, O’Connor RE. Black cohosh-induced hepatitis. Del Med J 2007; 79: 441-4. (50 year old woman developed abdominal pain 2 weeks after starting black cohosh [40 mg/day] for menopausal symptoms [bilirubin 1.1 mg/dL, ALT 691 U/L, Alk P 117 U/L], with rapid resolution on stopping). 18203607
Newton KM, Reed SD, LaCroix AZ, Grothaus LC, Erlich K, Guiltinan J. Treatment of vasomotor symptoms of menopause with black cohosh, multibotanicals, soy, hormone therapy, or placebo. Ann Intern Med 2006; 145: 869-79. (Controlled trial of black cohosh [160 mg/day], vs a multibotanical with black cohosh, vs a multibotanical with dietary soy, vs estrogen vs placebo in 351 women with vasomotor symptoms attributed to menopause found no difference between herbals and placebo in improving symptoms or in rates of adverse events; no hepatotoxicity or ALT results reported). 17179056
Briese V, Stammwitz U, Friede M, Henneicke-von Sapelin HH. Black cohosh with or without St. John’s wort for symptom-specific climacteric treatment–results of a large-scale, controlled, observational study. Maturitas 2007; 57: 405-14. (Open label observation study of 6141 women receiving either black cohosh alone or combined with St. John’s wort for menopausal symptoms showed similar improvements with either treatment; only 2.2% developed adverse events and there were no case of liver dysfunction reported, but laboratory data were not collected). 17590291
Gori L, Firenzuoli F. Is black cohosh a hepatotoxic medicinal herb? Forsch Komplementmed 2007; 14: 109-10. (The European Medicines Agency [EMEA] announced that 42 cases of liver injury attributed to black cohosh have been reported; however, authors argue that many cases were poorly documented and the possibility of contamination and other comorbidities raise issue of whether black cohosh was the cause; concluding that black cohosh hepatotoxicity is probably rare). 17464162
Committee on Herbal Medicinal Products, European Medicines Agency. Assessment of case reports connected to herbal medicinal products containing Cimicifugae racemosae rhizoma (black cohosh, root). 2006. Available at: https://www.ema.europa.eu/en/documents/public-statement/emea-public-statement-herbal-medicinal-products-containing-cimicifugae-racemosae-rhizoma-serious-hepatic-reactions_en.pdf (Assessment of reported cases of black cohosh hepatotoxicity by the Committee on Herbal Medicinal Products of the European Medicines Agency using the RUCAM scoring system, concluded that most cases were inadequately documented and only 3 could be considered possible and 2 probable).
Seeff LB. Herbal hepatotoxicity. Clin Liver Dis 2007; 11: 577-96. (Review of HDS associated hepatotoxicity, with review of the literature including 4 reports of hepatic injury due to black cohosh). 17723921
Dunbar K, Solga AF. Black cohosh, safety, and public awareness. Liver International 2007; 27: 1017-8. (41 year old woman developed fatigue 2 weeks after starting black cohosh and developed progressive jaundice, ascites and hepatic encephalopathy leading to transfer to a transplant center [bilirubin 13.1 mg/dL, ALT 393 U/L, INR 2.0], undergoing liver transplant 2.5 months after onset). 17696943
Walji R, Boon H, Guns E, Oneschuk D, Younus J. Black cohosh (Cimicifuga racemosa [L.] Nutt.): safety and efficacy for cancer patients. Support Care Cancer 2007; 15: 913-21. (Systematic review of literature of safety and efficacy of black cohosh in patients with cancer concluded that evidence for benefit as well as for liver toxicity was “inconclusive”). 17602247
Teschke R. Questions regarding causality in presumed black cohosh hepatotoxicity. Del Med J 2008; 80: 233-4; author reply 235. (Letter in response to Nisbet [2006] suggesting that symptoms predated time of starting black cohosh and that other diagnoses were not adequately excluded; reply by authors stating that symptoms arose soon after starting black cohosh and that other diagnoses were either excluded or highly unlikely). 18714667
Joy D, Joy J, Duane P. Black cohosh: a cause of abnormal postmenopausal liver function tests. Climacteric 2008; 11: 84-8. (Two cases: 50 year old woman developed headaches and mild AST [53-70 U/L] and GGT [213-571 U/L] elevations on black cohosh, which resolved on stopping; 51 year old woman developed abdominal pain and liver test abnormalities [bilirubin normal, ALT 722 U/L, Alk P 226 U/L] after taking black cohosh for 2 months, values normalizing within 2 weeks of stopping). 18202968
Chow EC, Teo M, Ring JA, Chen JW. Liver failure associated with the use of black cohosh for menopausal symptoms. Med J Aust 2008; 188: 420-2. (51 year old woman developed fatigue followed by jaundice 3 years after starting intermittent doses of black cohosh [20 mg daily], [bilirubin 6.2 mg/dL, ALT 1230 U/L, Alk P 191 U/L, INR 1.8], with progressive liver failure leading to liver transplantation; explant showed massive necrosis and collapse). 18393750
Borrelli F, Ernst E. Black cohosh (Cimicifuga racemosa) for menopausal symptoms: a systematic review of its efficacy. Pharmacol Res 2008; 58: 8-14. (Systematic review of six randomized placebo controlled trials of black cohosh in women with menopausal symptoms found no consistency in support of beneficial effects, but that such an effect could not be excluded; no discussion of adverse events). 18585461
Mahady GB, Low Dog T, Barrett ML, Chavez ML, Gardiner P, Ko R, Marles RJ, et al. United States Pharmacopeia review of the black cohosh case reports of hepatotoxicity. Menopause 2008; 15: 628-38. (Expert committee review of case reports of hepatotoxicity related to black cohosh from all possible sources found 30 separate reports, but on analysis none were considered “certain” or even “probable”, which, nevertheless, led to recommendation that black cohosh be labeled with a cautionary statement regarding liver injury). 18340277
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, none were attributed to black cohosh). 19159172
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications or dietary supplements, but none were attributed to black cohosh). 18955056
Pierard S, Coche JC, Lanthier P, Dekoninck X, Lanthier N, Rahier J, Geubel AP. Severe hepatitis associated with the use of black cohosh: a report of two cases and an advice for caution. Eur J Gastroenterol Hepatol 2009; 21: 941-5. (Two cases with histological features of chronic hepatitis during black cohosh therapy for menopausal symptoms: 62 year old woman developed abdominal pain 3 months after starting black cohosh [bilirubin normal, ALT 322 U/L, GGT 320 U/L, ANA 1:320], with resolution upon stopping [transient worsening when given prednisolone and azathioprine]; 58 year old woman developed fatigue sometime after starting black cohosh for menopausal symptoms [bilirubin normal, ALT 318 U/L, GGT 95 U/L], with persistence of abnormalities on continuing and rapid improvement upon stopping black cohosh: Case 3). 19404202
Naser B, Liske E. Teschke R. Liver failure associated with the use of black cohosh for menopausal symptoms. Med J Aust 2009; 190: 99-100; author reply 100. (Two letters in response to Chow [2008] raising the issue of alcohol as a cause of the liver injury and the possibility of other causes such as herpes simplex, adenovirus and Wilson disease; reply by authors stating that these etiologies were unlikely). 19236302
Teschke R. A U.S. review determined that black cohosh products should be labeled with a cautionary statement. Menopause. 2009;16:214. Author reply 214-5. (Letter in response to Mahady [2008] questioning the use of the Naranjo rather than the RUCAM scale in assessing causality in cases of black cohosh hepatotoxicity; authors reply stating that the causality assessment was done by expert consensus opinion and the Naranjo scale was used only as an aid). 19131847
Teschke R, Schwarzenboeck A. Suspected hepatotoxicity by Cimicifugae racemosae rhizoma (black cohosh, root): critical analysis and structured causality assessment. Phytomedicine 2009; 16: 72-84. (Among 42 reports of severe hepatotoxicity received by the European Medicine Agency, only 4 were considered as possible or probable; application of RUCAM to these 4 cases by the author yielded scores in the “excluded” range [-1 to -3], largely because of other possible diagnoses [autoimmune hepatitis, herpes] and other drugs used). 19010650
Teschke R, Bahre R, Fuchs J, Wolff A. Black cohosh hepatotoxicity: quantitative causality evaluation in nine suspected cases. Menopause 2009; 16: 956-65. (Analysis of 9 cases of suspected black cohosh hepatotoxicity using RUCAM suggested that none could be considered even possibly related, largely because of competing diagnoses, other medications being taken and lack of information on course and outcome). 19339903
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling and frequent underreporting of herbal use by patients. Black cohosh is discussed as a potential cause of severe acute hepatitis). 19826971
Vannacci A, Lapi F, Gallo E, Vietri M, Toti M, Menniti-Ippolito F, Raschetti R, et al. A case of hepatitis associated with long-term use of Cimicifuga racemosa. Altern Ther Health Med 2009; 15: 62-3. (37 year old woman developed jaundice 6-8 months after starting black cohosh for menopausal symptoms [bilirubin 1.5 mg/dL, ALT 20 times ULN, GGT slightly increased], with persistent ALT abnormalities until use of the herbal was admitted, resolution occurring within 1 month of stopping). 19472866
Guzman G, Kallwitz ER, Wojewoda C, Chennuri R, Berkes J, Layden TJ, Cotler SJ. Liver injury with features mimicking autoimmune hepatitis following the use of black cohosh. Case Rep Med 2009; 2009: 918156. (Two women, ages 42 and 53, developed fatigue 6 and 8 months after starting black cohosh for menopausal symptoms [bilirubin 3.1 and 2.0 mg/dL, ALT 1457 and 443 U/L, Alk P 94 and 188 U/L, ANA 1:20-1:40], biopsy showing changes suggestive of chronic hepatitis and both responding to corticosteroids). 20130783
Mahady G, Low Dog T, Sarma DN, Giancaspro GI. Suspected black cohosh hepatotoxicity—causality assessment versus safety signal. Maturitas 2009; 64: 139-40. (Letter in response to Teschke [2009] mentioning that there have been 82 reports of hepatotoxicity attributed to black cohosh and that a product warning is warranted). 19781876
Betz JM, Anderson L, Avigan MI, Barnes J, Farnsworth NR, Gerdén B, Henderson L, et al. Black Cohosh: considerations of safety and benefit. Nutrition Today 2009; 44: 155-62. (Summary of a 2007 NIH workshop on the safety of black cohosh and making recommendations for future research and analysis).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous adverse event reports of herbals to the Swedish Registry includes 38 [5%] related to black cohosh, including 3 related to enzyme elevations and 3 various hepatic reactions). 19650152
Barnes J. Black cohosh (black snakeroot, Cimicifuga racemosa (L.) Nutt., Actaea racemosa L.). J Prim Health Care 2010; 2: 79-80. (Review mentions that a systematic review conducted in 2007 of 6 controlled trials of black cohosh extracts in 1112 women found evidence of efficacy to be "uncertain" and several spontaneous reports of hepatotoxicity have been published). 20690409
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, 1 to black cohosh). 20949552
Teschke R. Black cohosh and suspected hepatotoxicity: inconsistencies, confounding variables, and prospective use of a diagnostic causality algorithm. A critical review. Menopause 2010; 17: 426-40. (Author performed a reanalysis of 69 cases of suspected liver injury from black cohosh using RUCAM and concluded that 27 were excluded, 21 unlikely, 8 unrelated, 12 unassessable, and only 1 possibly related). 20216279
Mahady G, Low Dog T, Sarma ND, Giancaspro GI, Griffiths J. The causal relationship between the use of black cohosh-containing products and hepatotoxicity. Menopause 2010; 17: 1088-9; author reply 1089. (Letter in response to Teschke [2010] arguing that the modified RUCAM he used made most cases unassessable and that several groups have agreed that black cohosh has a "signal of safety concern"; author replies addressing the need of an improved causality instrument). 20827114
Painter D, Perwaiz S, Murty M. Black cohosh products and liver toxicity: update. Canadian Adverse Reaction Newsl 2010; 20: 12. (Among 4 cases of suspected black cohosh hepatotoxicity reported to Health Canada, analysis of retrieved samples showed that none contained authentic black cohosh, but had phytochemical profiles consistent with presence of other related herbal species).
Firenzuoli F, Gori L, Roberti di Sarsina P. Black Cohosh Hepatic Safety: Follow-Up of 107 patients consuming a special Cimicifuga racemosa rhizome herbal extract and review of literature. Evid Based Complement Alternat Med 2011; 2011: 821392. (Among 107 women treated with black cohosh extract for at least one year, none had clinical or biochemical evidence of liver injury). 21660145
Jiang B, Ma C, Motley T, Kronenberg F, Kennelly EJ. Phytochemical fingerprinting to thwart black cohosh adulteration: a 15 Actaea species analysis. Phytochem Anal 2011; 22: 339-51. (Analysis of 15 Actaea species by HPLC and LC-MS methods showed a characteristic pattern of polyphenols and triterpene glycosides in Actaea racemosa extracts; a specific marker compound [cimifugin] was found in most other species, but not racemosa [black cohosh]). 21337649
Naser B, Schnitker J, Minkin MJ, de Arriba SG, Nolte KU, Osmers R. Suspected black cohosh hepatotoxicity: no evidence by meta-analysis of randomized controlled clinical trials for isopropanolic black cohosh extract. Menopause 2011; 18: 366-75. (Metaanalysis of 5 randomized controlled trials of black cohosh [Remifemin] found no significant changes in mean ALT, AST or GGT levels among black cohosh and placebo recipients; among 7 patients who developed significant rises in liver tests during therapy, none were judged to be related to black cohosh therapy). 21228727
Teschke R, Schmidt-Taenzer W, Wolff A. Spontaneous reports of assumed herbal hepatotoxicity by black cohosh: is the liver-unspecific Naranjo scale precise enough to ascertain causality? Pharmacoepidemiol Drug Saf 2011; 20: 567-82. (2 cases of suspected black cohosh hepatotoxicity were evaluated by the RUCAM and Naranjo causality scales: scores ranged from -2 to +2 by RUCAM [none even possible] and -1 to +2 by Naranjo [6 possible]). 21702069
Teschke R, Schwarzenboeck A, Schmidt-Taenzer W, Wolff A, Hennermann KH. Herb induced liver injury presumably caused by black cohosh: a survey of initially purported cases and herbal quality specifications. Ann Hepatol 2011; 10: 249-59. (Review of problems of causality assessment in cases of liver injury attributed to herbal medications focusing upon black cohosh). 21677326
Mahady G, Low Dog T, Sarma ND, Griffiths J, Giancaspro GI. Response to Teschke et al. Pharmacoepidemiol Drug Saf 2012; 21: 339-40; author reply 336-8. (Letter in response to Teschke [2011] arguing that the calculation of RUCAM scores was based upon the author's modifications of the scoring system that resulted in all cases being unlikely or excluded). 22407603
Wang YJ, Dou J, Cross KP, Valerio LG Jr. Computational analysis for hepatic safety signals of constituents present in botanical extracts widely used by women in the United States for treatment of menopausal symptoms. Regul Toxicol Pharmacol 2011; 59: 111-24. (Computer analyses of chemical structures of compounds found in botanicals used to treat menopausal symptoms identified several predicted to cause hepatic injury, including protocatechuic acid in black cohosh). 20920542
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but neither black cohosh or Cimicifuga racemosa are listed). 22928722
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of the literature on HDS associated hepatotoxicity mentions that black cohosh has been implicated in causing liver injury in at least 6 publications). 23121117
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period [2010-12], including 15 attributed to herbals or dietary supplements, but none specifically to black cohosh). 23419359
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of herbal hepatotoxicity including discussion of black cohosh, which has been linked to liver injury ranging from asymptomatic increases in ALT levels to acute liver failure and hepatitis with autoimmune features). 24099027
Abdualmjid RJ, Sergi C. Hepatotoxic botanicals - an evidence-based systematic review. J Pharm Pharm Sci 2013; 16: 376-404. (Extensive review of the hepatotoxicity of botanicals mentions the main active constituents of black cohosh are terpene glycosides and discusses 3 case reports of serious liver injury from its use). 24021288
Lim TY, Considine A, Quaglia A, Shawcross DL. Subacute liver failure secondary to black cohosh leading to liver transplantation. BMJ Case Rep 2013; 2013. pii: cr2013009325. (60 year old woman developed jaundice 2 weeks after starting black cohosh for menopausal symptoms [bilirubin 27.7 mg/dL, AST 2385 U/L, Alk P 151 U/L, INR 1.57], with progressive worsening requiring liver transplantation 3 weeks later). 23833086
Enbom ET, Le MD, Oesterich L, Rutgers J, French SW. Mechanism of hepatotoxicity due to black cohosh (Cimicifuga racemosa): Histological, immunohistochemical and electron microscopy analysis of two liver biopsies with clinical correlation. Exp Mol Pathol 2014; 96: 279-83. (Two women, ages 65 and 55 years, developed jaundice while taking black cohosh preparations for an unknown period [peak bilirubin 6.6 and 5.4 mg/dL, ALT 92 and 2061 U/L, Alk P 368 and 156 U/L], resolving within 3 months of stopping). 24657312
Cimicifuga: liver transplantation. Prescrire Int 2013; 22: 73. (Brief report that the UK Drug Regulatory Agency has received 36 spontaneous reports of hepatic injury due to black cohosh and one instance of severe hepatitis requiring liver transplantation). 23593697
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol 2013; 25: 1093-8. (Review of 23 case series of herb induced liver disease found alternative possible diagnoses for 278 of 573 cases including 58 of 94 cases [62%] attributed to black cohosh). 23510966
Masada-Atsumi S, Kumeta Y, Takahashi Y, Hakamatsuka T, Goda Y. Evaluation of the botanical origin of black cohosh products by genetic and chemical analyses. Biol Pharm Bull 2014; 37: 454-60. (Testing of commercial black cohost products from the US and Europe by DNA fingerprinting found that half were derived from Cimicifuga dahurica rather than C. racemosa and liquid chromatography followed by tandem mass spectroscopy showed that one third of products were contaminated with plant species other than C. racemosa). 24583864
Muqeet Adnan M, Khan M, Hashmi S, Hamza M, Abdul Mujeeb S, Amer S. Black cohosh and liver toxicity: is there a relationship? Case Rep Gastrointest Med 2014; 2014: 860614. (44 year old woman developed jaundice one month after starting black cohosh for menopausal symptoms [bilirubin 20 mg/dL, ALT 215 U/L, Alk P 201 U/L, INR 1.2], resolving within 3 months of stopping the herbal product). 25093128
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, one was attributed to a product containing black cohosh: remifemin). 25043597
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], one of which was attributed to Remifemin, a product advertised as helpful for menopausal symptoms that contains black cohosh [Navarro et al. Hepatology 2014]). 25754159
Ulbricht C, Windsor RC. An evidence-based systematic review of black cohosh(Cimicifuga racemosa, Actaea racemosa) by the Natural Standard Research Collaboration. J Diet Suppl 2015; 12: 265-358. (A 357 page “evidence-based” review of the safety and efficacy of black cohosh states: “Case reports have indicated that in certain individuals, hepatic failure is possible”). 25153652
Tanmahasamut P, Vichinsartvichai P, Rattanachaiyanont M, Techatraisak K, Dangrat C, Sardod P. Cimicifuga racemosa extract for relieving menopausal symptoms: a randomized controlled trial. Climacteric 2015; 18: 79-85. (Among 54 women with menopausal symptoms treated with black cohosh [40 mg daily] or placebo for 12 weeks, symptoms improved in both groups to a similar extent, there were no serious adverse events, and serum mean ALT and AST levels did not change appreciably). 24941138
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17: 537. (Listing of published cases of liver injury from HDS products, does not list publications on black cohosh or Cimicifuga species). 27070596
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107: 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists 16 publications implicating black cohosh [Actaea racemose] in liver injury, including hepatitis, hepatic failure and deaths). 27402097
Franco DL, Kale S, Lam-Himlin DM, Harrison ME. Black cohosh hepatotoxicity with autoimmune hepatitis presentation. Case Rep Gastroenterol 2017; 11: 23-28. (69 year old woman developed abdominal pain followed by dark urine and jaundice 3 weeks after starting black cohosh [150 mg daily] for menopausal symptoms [bilirubin 6.3 mg/dL, ALT 2385 U/L, Alk P 296 U/L, INR 1.0, ANA and SMA positive], with rapid improvement on stopping the herbal product and initiation of prednisone and azathioprine which were stopped 3 and 6 months later, with normal liver tests thereafter). 28203134
Svedlund E, Larsson M, Hägerkvist R. Spontaneously reported adverse reactions for herbal medicinal products and natural remedies in Sweden 2007-15: report from the Medical Products Agency. Drugs Real World Outcomes 2017; 4: 119-25. (A total of 116 spontaneous reports of adverse reactions to herbal products were received by a Swedish registry between 2007 and 2015, including 15 related to black cohosh, 5 of which were considered “severe” and all 5 were related to liver injury; details were not provided). 28353157
Guo Y, Yin T, Wang X, Zhang F, Pan G, Lv H, Wang X, et al. Traditional uses, phytochemistry, pharmacology and toxicology of the genus Cimicifuga: A review. J Ethnopharmacol 2017; 209: 264-82. (Extensive review of the botanical characteristics, traditional medical uses, phytochemistry, quality control and potential mechanisms of action of the genus Cimicifuga which includes at least 28 species, that are widely distributed, C. racemose in the Americans and C. dahurica, foetida and hercleifolia in Asia, the bioactive components are believed to be the triterpene glycosides which constitute 2-6% of the herbal extracts isolated largely from dried rhizomes; mentions that hepatotoxicity is a possible adverse event associated with its use). 28826891
Gao L, Zheng T, Xue W, Wang Y, Deng Y, Zuo H, Sun A. Efficacy and safety evaluation of Cimicifuga foetida extract in menopausal women. Climacteric 2018; 21: 69-74. (Among 96 postmenopausal women treated with either one of two fixed combinations of estrogen and progesterone or with C. foetida extract daily for 24 months, improvements in menopausal symptoms were similar across groups and there were no serious adverse events and no differences in serum ALT levels in the three groups during treatment). 29198157
Hoban CL, Byard RW, Musgrave IF. Analysis of spontaneous adverse drug reactions to echinacea, valerian, black cohosh and ginkgo in Australia from 2000 to 2015. J Integr Med 2019; 17: 338-43. (Among spontaneous adverse drug events reported to the Australian Therapeutic Goods Administration between 2000 and 2015, 35 were attributed to black cohosh, all in women, ages 51 to 75 years, and 13 were liver related; no details provided). 31113761
Patel R, Alavi F, Ortega S, Matela A. Herb-induced liver injury by Cimicifuga racemosa and Thuja occidentalis herbal medications for fertility. Case Rep Gastrointest Med. 2021;2021:8858310. (40 year old woman developed abdominal pain one month after starting solutions of Cimicifuga [black cohosh] and Thuja [arborvitae] for infertility [bilirubin 0.6 mg/dL, ALT 238 U/L, Alk P 102 U/L], which resolved without jaundice or worsening liver tests within a month of stopping). 33532101
Brar HS, Marathi R. Case of cholestatic drug-induced liver injury (DILI) associated with black cohosh. BMJ Case Rep. 2021;14:e240408. (50 year old woman developed fatigue, pruritus, and jaundice 2 months after starting black cohosh and presented with continued symptoms despite stopping 2 months later [bilirubin 27.9 mg/dL, ALT 33 U/L, Alk P 201 U/L, INR 1.06], biopsy showing canalicular cholestasis, mild inflammation, and sinusoidal dilatation, jaundice resolving 3 months after presentation). 33962922
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48], but only 15 cases attributed to black cohosh, making it rank #15 in frequency). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], but none were attributed to black cohosh). 33434654
Likhitsup A, Chen VL, Fontana RJ. Estimated exposure to 6 potentially hepatotoxic botanicals in us adults. JAMA Netw Open. 2024;7:e2425822. (Analysis of NHANES survey of herbal use in the US between 2017 and 2020 found that 6 botanicals that have been linked to instances of liver injury were commonly used, including turmeric [n=236], green tea [92], ashwagandha [28], garcinia [20], red yeast rice [20], and black cohosh [19]). 39102266

## OTHER REFERENCE LINKS

1. Recent References on Black Cohosh: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Black+Cohosh+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Black Cohosh: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Black%20Cohosh)